# Bilberry

## OVERVIEW

### Introduction

Bilberry is a popular herb used alone or as a component of multiingredient herbal products that has several purported uses including improving stamina, weight control, mental concentration and vision as well as various gastrointestinal, kidney, rheumatologic and vascular conditions. Neither fresh bilberries nor fruit or plant extracts have been implicated in causing serum enzyme elevations during treatment or clinically apparent acute liver injury.

### Background

Bilberry is a popular herbal product derived from the berries and leaves of the bilberry plant (Vaccinium myrtillus), a deciduous, perennial shrub native to Europe and North America which produces dark purple berries resembling blueberries. Typically, bilberry is prepared from the berries or leaves and contains anthocyanidins and tannins which are claimed to contain astringent, antioxidant and antiseptic activities. In traditional medicine, bilberry was used to treat varicose veins, venous insufficiency, fatigue, diarrhea and gastrointestinal complaints. Small clinical trials have assessed its effectiveness in treating multiple medical conditions including chronic venous insufficiency, varicose veins, diabetes, irritable bowel syndrome, ulcerative colitis, glaucoma, eye strain, myopia and dysmenorrhea. It has also been assessed as a weight loss agent and as a means of improving night vision. However, rigorous evidence for its efficacy in any these conditions is lacking. Bilberry (typically extracts of the fruit) is available as capsules and tablets of varying concentrations, ranging from 40 to 1000 mg. The typical dose varies greatly from 80 to 1000 mg once or twice daily. Side effects are few and generally mild and may include gastrointestinal symptoms of nausea or abdominal discomfort.

### Hepatotoxicity

Despite widespread use, bilberry has not been specifically linked to liver injury, either in the form of transient serum enzyme elevations or clinically apparent acute liver injury. Bilberry demonstrates minimal effect on drug metabolism but may affect platelet aggregation and predispose to excessive bleeding in patients on anticoagulants such as warfarin.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Dyeberry, Huckleberry, Whortleberry, Wineberry Hurts

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bilberry – Generic

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING

Fact Sheet at National Center for Complementary and Integrative Health (https://nccih.nih.gov/health/bilberry)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bilberry | 84082-34-8 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2019

Abbreviations used: HDS, herbal and dietary supplements

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; bilberry is not discussed).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements published in 2007; bilberry is not listed).
Bilberry. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 78-82. (Compilation of short monographs on herbal medications and dietary supplements).
Canter PH, Ernst E. Anthocyanosides of Vaccinium myrtillus (bilberry) for night vision--a systematic review of placebo-controlled trials. Surv Ophthalmol 2004; 49: 38-50. (A systematic review identified 12 clinical trials of bilberry for night vision, only 5 of which were placebo controlled and results provided no evidence that bilberry improves night vision in healthy subjects; bilberry was well tolerated with few and mostly minor gastrointestinal complaints in clinical trials and in postmarketing surveillance studies). 14711439
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, but none were attributed to bilberry use). 15390328
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to a Spanish registry, 13 [2%] were due to herbals, but none were attributed to bilberry). 19159172
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry, none of which were attributed to bilberry). 19650152
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; bilberry is not listed as a potentially hepatotoxic botanical). 19826971
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to HDS, but none incriminated bilberry). 20949552
Stickel F, Kessebohm K, Weimann R, Seitz HK. Review of liver injury associated with dietary supplements. Liver Int 2011; 31: 595-605. (Review of liver injury from HDS focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, and Chinese herbs; does not mention bilberry). 21457433
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and supplements, does not list bilberry or vaccinium myrtillus). 22928722
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 attributed to HDS products none of which were attributed to bilberry). 23419359
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to bilberry). 25043597
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-32. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver does not specifically discuss or mention bilberry). 25500423
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products does not mention bilberry). 27070596
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products; does not list bilberry among products linked to liver injury). 27402097
Belcaro G, Dugall M, Luzzi R, Corsi M, Ledda A, Ricci A, Pellegrini L, et al. Management of varicose veins and chronic venous insufficiency in a comparative registry with nine venoactive products in comparison with stockings. Int J Angiol 2017; 26: 170-8. (Registry of 1051 otherwise healthy patients with chronic venous insufficiency assessed 9 products including bilberry [Mirtoselect] found “no safety or tolerability problems”). 28804235

## OTHER REFERENCE LINKS

1. Recent References on Bilberry: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=cascara+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bilberry: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=cascara)